# Oseltamivir

## OVERVIEW

### Introduction

Oseltamivir is an inhibitor of the influenza neuraminidase enzyme and is used as therapy and prophylaxis against influenza A and B. Oseltamivir has not been associated with clinically apparent liver injury.

### Background

Oseltamivir (oh" sel tam' i vir) phosphate is an ester prodrug of an antiviral enzyme inhibitor which, after absorption, is converted in the liver to oseltamivir carboxylase, the active intermediate. Oseltamivir carboxylase is a potent inhibitor of the enzyme neuraminidase of the influenza virus particle. Inhibition of this enzyme causes a decrease in viral replication, probably as a result of interference with particle formation and release. Oseltamivir is active against both influenza A and B virus, but has no activity against other common upper respiratory tract viruses. In addition, resistance to oseltamivir can develop rapidly. Oseltamivir is indicated for therapy or post-exposure prevention of influenza A and B in both children and adults. Oseltamivir was approved for in the United States in 1999 and is commonly used during influenza outbreaks. Oseltamivir is available as capsules of 30, 45 and 75 mg and as an oral suspension (6 mg/mL) generically and under the brand name of Tamiflu. The recommended oral dose for therapy in adults is 75 mg twice daily for 5 days; the usual prophylactic dose is 75 mg once daily for 10 days, starting within 2 days of close contact with an infected person. Side effects are uncommon and include mild nausea, gastrointestinal upset, dizziness and headache. Serious adverse events are rare but can include hypersensitivity reactions, Stevens Johnson syndrome and neuropsychiatric syndromes such as disorientation, hallucinations and mania.

### Hepatotoxicity

In clinical trials of oseltamivir, serum aminotransferase elevations occurred in 2% of treated subjects, but were asymptomatic and transient in all and there were no reports of clinically apparent liver injury with jaundice. The rates of ALT elevations with oseltamivir were generally similar to those treated with placebo or with a comparative agents. Since its approval in 1999, oseltamivir has been widely used during influenza seasonal outbreaks. There have been a few, isolated reports of mild liver injury in patients receiving oseltamivir, but the relationship of the injury with oseltamivir has not always been very convincingly shown. There have been no reports of acute liver failure or chronic liver disease attributed to oseltamivir use. Furthermore, a proportion of patients with influenza have serum enzyme elevations and even mild jaundice during the acute illness, independent of any therapy.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

Oseltamivir is metabolized by the liver to the active intermediate oseltamivir carboxylate, but has little further hepatic metabolism and is excreted largely in the urine. The rapid onset of liver injury attributed to oseltamivir in case reports and the occurrence of hypersensitivity reactions such as Stevens Johnson syndrome suggest that immunoallergic factors are responsible. The typical course of oseltamivir is for 5 to 10 days only,

and the brief exposure and minimal hepatic metabolism may account for why hepatotoxicity is rare.

### Management and Outcome

The case reports of liver injury associated with oseltamivir therapy have been mild and self-limited without specific therapy. Oseltamivir should be discontinued promptly if liver injury with symptoms or jaundice arise and reexposure should be avoided. There is no information on cross sensitivity to liver injury or hypersensitivity reactions among the various neuraminidase inhibitors that are used to treat influenza.

Drug Class: Antiviral Agents

Other Drugs in the Class for Influenza: Amantadine, Baloxavir, Peramivir, Rimantadine, Zanamivir

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Oseltamivir – Generic, Tamiflu®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Oseltamivir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Oseltamivir | 196618-13-0 | C16-H28-N2-O4

## ANNOTATED BIBLIOGRAPHY

References updated: 22 June 2020

Zimmerman HJ. Antiviral agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 621-3. (Expert review of antiviral agents and liver injury published in 1999; amantadine and rimantadine have not caused "overt hepatic injury"; oseltamivir is not mentioned).
Núñez M. Influenza virus treatments. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 513. (Review of hepatotoxicity of antiviral agents; oseltamivir is not discussed).
Acosta EP. Antiviral agents (nonretroviral). In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1105-18. (Textbook of pharmacology and therapeutics).
Nicholson KG, Aoki FY, Osterhaus AD, Trottier S, Carewicz O, Mercier CH, Rode A, et al. (2000). Efficacy and safety of oseltamivir in treatment of acute influenza: a randomised controlled trial. Neuraminidase Inhibitor Flu Treatment Investigator Group. Lancet. (Controlled trial in 726 adults given oseltamivir in two doses or placebo for 5 days; laboratory results "did not differ significantly from baseline" for any group; no serious adverse events, and no hepatitis or jaundice mentioned).
Treanor JJ, Hayden FG, Vrooman PS, Barbarash R, Bettis R, Riff D, Singh S, et al. (2000). Efficacy and safety of the oral neuraminidase inhibitor oseltamivir in treating acute influenza: a randomized controlled trial. US Oral Neuraminidase Study Group. JAMA. (Controlled trial in 629 adults given oseltamivir in two doses or placebo for 5 days; no drug related serious adverse events, and standard laboratory tests did not change significantly in any group).
McNicholl IR, McNicholl JJ. (2001). Neuraminidase inhibitors: zanamivir and oseltamivir. Ann Pharmacother. (Review of efficacy and safety of both zanamivir and oseltamivir; no mention of hepatotoxicity or ALT elevations).
Doucette KE, Aoki FY. (2001). Oseltamivir: a clinical and pharmacological perspective. Expert Opin Pharmacother. (Review of structure, pharmacology, antiviral activity, efficacy and safety of oseltamivir; no mention of ALT elevations or hepatotoxicity).
Dutkowski R, Thakrar B, Froehlich E, Suter P, Oo C, Ward P. (2003). Safety and pharmacology of oseltamivir in clinical use. Drug Saf. (More than 11,000 subjects evaluated in premarketing studies and more than 4 million prescriptions worldwide, 2300 spontaneous reports of adverse events received, largely for gastrointestinal upset and rash; no hepatic adverse events reported).
Jones M, Del Mar C. (2006). Safety of neuraminidase inhibitors for influenza. Expert Opin Drug Saf. (Neuraminidase inhibitors include oseltamivir and zanamivir [given by inhalation]; nausea is the only side effect found to be more common with receipt of oseltamivir vs placebo).
Jefferson T, Demicheli V, Rivetti D, Jones M, Di Pietrantonj C, Rivetti A. (2006). Antivirals for influenza in healthy adults: systematic review. Lancet. (Analysis of 51 reports of 52 controlled trials of antivirals for influenza; "Neuraminidase inhibitors are not associated with any adverse events when used as treatment as opposed to prophylaxis").
(2009). Antiviral drugs for influenza. Med Lett Drugs Ther. (Review of status of antiviral agents for prevention and treatment of influenza A and B).
Dutkowski R, Smith JR, Davies BE. (2010). Safety and pharmacokinetics of oseltamivir at standard and high dosages. Int J Antimicrob Agents. (Assessment of safety of higher doses [250-900 mg daily] of oseltamivir in 391 volunteers; headache, nausea and dizziness were common; laboratory data showed no significant changes from baseline or differences from placebo).
Smith EV, Pynn MC, Blackford S, Leopold DJ. (2010). Stevens-Johnson syndrome secondary to oseltamivir (Tamiflu). Br J Gen Pract. (17 year old male developed rash and oral ulceration diagnosed as Stevens Johnson Syndrome 2 weeks after an influenza-like illness and treatment with oseltamivir and acetaminophen; no mention of liver test results).
de Miguel-Bouzas JC, Castro-Tubío E, Freire-Vázquez MC. (2010). Hepatitis aguda en paciente a tratamiento con oseltamivir. Farm Hosp. (32 year old woman with suspected [but unconfirmed] influenza was found to have abnormal liver tests the day after starting oseltamivir and acetaminophen [bilirubin not given, ALT 139 rising to 834 U/L, Alk P 90 rising to 285 U/L], with peak of values at day 4 and rapid improvement once oseltamivir was stopped and near normal values by day 14).
Yingying C. (2011). Abnormal liver chemistry in patients with influenza A H1N1. Liver Int. (Among 131 patients admitted to a hospital for influenza A H1N1, 13% had abnormal ALT and 5% abnormal Alk P elevations, but the range of values was not provided).
(2014). Antiviral drugs for influenza 2013-2014. Med Lett Drugs Ther. (Concise summary of safety and efficacy of medications for influenza appropriate for the 2013-14 season mentions that adverse effects of oseltamivir include nausea, vomiting and headache; no mention of liver injury).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to a drug used to treat influenza).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 12 cases [1.3%] were attributed to antiviral agents, but none to antivirals used to treat influenza).
Marty FM, Vidal-Puigserver J, Clark C, Gupta SK, Merino E, Garot D, Chapman MJ, et al. (2017). Intravenous zanamivir or oral oseltamivir for hospitalized patients with influenza: an international, randomised, double-blind, double-dummy, phase 3 trial. Lancet Respir Med. (Among 626 patients with symptoms of influenza [488 confirmed] treated with zanamivir [300 or 600 mg] or oseltamivir twice daily for 5-10 days, time to clinical improvement was similar in all three groups as were adverse events including respiratory failure and death; ALT elevations arose in 1.2% of zanamivir vs 2.0% of oseltamivir treated subjects).
Fang S, Qi L, Zhou N, Li C. (2018). Case report on alimentary tract hemorrhage and liver injury after therapy with oseltamivir: A case report. Medicine (Baltimore). (6 year old boy was treated for influenza like symptoms with ibuprofen [100 mg three times daily] and oseltamivir [60 mg twice daily] after the second dose of which he developed hematemesis and was found to have liver test abnormalities [bilirubin 0.4 rising to 4.9 mg/dL, ALT 80 rising to 193 U/L], resolving rapidly upon stopping both drugs).
(2019). Antiviral drugs for treatment and prophylaxis of seasonal influenza. Med Lett Drugs Ther. (Concise review of the drug therapy of influenza mentions that there are no data suggesting the superiority of one drug over another, they are all approved for treatment of uncomplicated influenza, should be started as soon as possible, and have been shown to shorten the duration of symptoms by one day in adults; no mention of ALT elevations or hepatotoxicity of any of the neuraminidase inhibitors).
Abraham GM, Morton JB, Saravolatz LD. (2020). Baloxavir: a novel antiviral agent in the treatment of influenza. Clin Infect Dis. (Review of the mechanism of action, microbiology, indications, clinical efficacy and toxicity of baloxavir mentions that adverse event rates are similar to those of oseltamivir and not much greater than placebo; no discussion of ALT elevations or hepatotoxicity).
Yu Y, Nie X, Song Z, Xie Y, Zhang X, Du Z, Wei R, et al. (2020). Signal detection of potentially drug-induced liver injury in children Using electronic health records. Front Pediatr. (Using electronic medical records from over 200,000 Chinese children hospitalized between 2010 and 2018 with more than 49 million blood test results, the authors identified 12 drugs that were associated with ALT elevations in excess of expected, one of which was oseltamivir; no specific details given).
Baker J, Block SL, Matharu B, Burleigh Macutkiewicz L, Wildum S, Dimonaco S, et al. (2020). Baloxavir marboxil single-dose treatment in influenza-infected children: a randomized, double-blind, active controlled phase 3 safety and efficacy trial (miniSTONE-2). Pediatr Infect Dis J. (Among 173 children less than 12 years old with influenza who were treated with a single dose of intravenous baloxavir or a 5 day course of oral oseltamivir, rates of clinical improvement were similar with the two regimens as were rates of adverse events [57% vs 46%] and there were no serious adverse events or deaths).
(2020). Antiviral drugs for influenza. Med Lett Drugs Ther. (Concise review of the drug therapy of influenza mentions that there is no evidence that one drug is more effective than any other in treating uncomplicated influenza infections but that oseltamivir is preferred for treatment of pregnant women, hospitalized patients and those with severe, complicated or progressive illness; common side effects of oseltamivir include nausea, vomiting and headache; no mention of ALT elevations or hepatic adverse events).

## OTHER REFERENCE LINKS

1 Recent References on Oseltamivir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Oseltamivir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Oseltamivir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Oseltamivir)